# Acrivastine

## OVERVIEW

### Introduction

Acrivastine is a second generation antihistamine that is used for the treatment of allergic rhinitis. Acrivastine has not been linked to instances of clinically apparent acute liver injury.

### Background

Acrivastine (ak" ri vas' teen) is a second generation antihistamine (H1 receptor blocker) that is used to treat allergic symptoms associated with hay fever, seasonal allergies, urticaria, angioedema and atopic dermatitis. Acrivastine, like other second generation antihistamines, is considered to be nonsedating, and prospective studies have shown that sedation is less common with acrivastine than first generation antihistamines such as diphenhydramine. In the United States, acrivastine is available in combination with pseudoephrine (Semprex-D) as therapy of seasonal allergic rhinitis. Acrivastine has been less popular than other second generation antihistamines such as loratadine and cetirizine, probably because it requires three times a day dosing. The recommended dose in adults is 4 to 8 mg two or three times daily. Common side effects include blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Although considered to be a nonsedating antihistamine, acrivastine may cause mild drowsiness particularly at higher doses. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Acrivastine has not been linked to liver enzyme elevations or to instances of clinically apparent liver injury. Its relative safety may relate to its rapid metabolism and use in low dosages.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acrivastine (with Pseudoephrine) – Semprex-D®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acrivastine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acrivastine | 87848-99-5 | C22-H24-N2-O2 | Acrivastine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Acrivastine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Acrivastine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Acrivastine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acrivastine)